# Rimantadine

## OVERVIEW

### Introduction

Rimantadine is an antiviral agent used as therapy for influenza A. Rimantadine has not been associated with clinically apparent liver injury.

### Background

Rimantadine (ri man' ta deen) is a cyclic primary amine that has antiviral and anti-Parkinsonian activities. The antiviral activity of rimantadine is attributed to inhibition of virion uncoating and release of viral RNA in the initial stages of viral replication. Rimantadine is active only against influenza A virus and has no activity against influenza B or other upper respiratory viruses. In addition, resistance to rimantadine with cross reactivity against amantadine can develop rapidly and is now common. The anti-Parkinsonian activity of rimantadine appears to be due to its effects on release of dopamine in the substantia nigra; however, it has not been developed or approved for this indication. Rimantadine was approved for treatment and prevention of influenza A in the United States in 1993 but is no longer recommended because of high rates of resistance and availability of more effective antiviral agents for influenza. Rimantadine is available as tablets of 100 mg and as syrup (50 mg/5 mL) in generic forms and under the brand name of Flumadine. The recommended dose for influenza in adults is 100 mg twice daily for 5-7 days; rimantadine can also be used as prophylaxis starting as soon as possible after close personal exposure. Side effects may include anxiety, dizziness, ataxia, confusion, fatigue, headache, insomnia, dry mouth and gastrointestinal upset.

### Hepatotoxicity

Despite widespread use, there is little evidence that rimantadine when given orally causes liver injury, either in the form of serum enzyme elevations or clinically apparent liver disease.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Rimantadine has minimal hepatic metabolism and is excreted largely unchanged in the urine, factors which perhaps explain the absence of significant hepatotoxicity.

Drug Class: Antiviral Agents

Other Drugs in the Class for Influenza: Amantadine, Baloxavir, Oseltamivir, Peramivir, Zanamivir

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Rimantadine – Generic, Flumadine®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Rimantadine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Rimantadine | 13392-28-4 | C12-H21-N

## ANNOTATED BIBLIOGRAPHY

References updated: 10 June 2020

Zimmerman HJ. Antiviral agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 621-3. (Expert review of antiviral agents and liver injury published in 1999; both amantadine and rimantadine appear to have "no adverse effect on the liver").
Núñez M. Influenza virus treatments. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 513. (Review of hepatotoxicity of antiviral agents; amantadine has been linked to rare instances of liver enzyme elevations).
Acosta EP. Antiviral agents (nonretroviral). In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1105-18. (Textbook of pharmacology and therapeutics).
Jefferson T, Demicheli V, Di Pietrantonj C, Rivetti D. (2006). Amantadine and rimantadine for influenza A in adults. Cochrane Database Syst Rev. (Systematic review of efficacy of amantadine and rimantadine in treatment and prevention of influenza A; side effects are frequent, but largely consist of dizziness, insomnia, lightheadedness and headache; no mention of liver test abnormalities or hepatitis).
(2009). Antiviral drugs for influenza. Med Lett Drugs Ther. (Review of status of antiviral agents for prevention and treatment of influenza A and B; rates of resistance to amantadine and rimantadine are high, making these agents poorly effective; no mention of liver toxicity).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 8 were attributed to antiviral agents, but none to drugs used in therapy of influenza).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 16 [1.8%] were attributed to antiviral agents, but none to rimantadine or other drugs for influenza).
(2017). Antiviral drugs for seasonal influenza 2016-2017. Med Lett Drugs Ther. (Review of status of antiviral agents for prevention and treatment of influenza A and B during the 2016-2017 season, discusses the neuraminidase inhibitors, but does not discuss or recommend amantadine or rimantadine).
(2019). Antiviral drugs for treatment and prophylaxis of seasonal influenza. Med Lett Drugs Ther. (Concise review of the drug therapy of influenza mentions that there are no data suggesting the superiority of one neuraminidase inhibitor over another, they are all approved for treatment of uncomplicated influenza, should be started as soon as possible, and have been shown to shorten the duration of symptoms by one day in adults; mentions that rimantadine and amantadine are no longer recommended for treatment of influenza because of high rates of resistance in circulating strains of influenza A and they are ineffective against influenza B).
(2020). Antiviral drugs for influenza. Med Lett Drugs Ther. (Concise review of the drug therapy of influenza mentions that there is no evidence that one neuraminidase inhibitor or baloxavir is more effective than any other in treating uncomplicated influenza infections but that oseltamivir is preferred for treatment of pregnant women, hospitalized patients and those with severe, complicated or progressive illness; mentions that rimantadine and amantadine are no longer recommended for treatment of influenza because of high rates of resistance in circulating strains of influenza A and they are ineffective against influenza B).

## OTHER REFERENCE LINKS

1 Recent References on Rimantadine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Rimantadine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Rimantadine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Rimantadine)